# Lanadelumab

## OVERVIEW

### Introduction

Lanadelumab is a human IgG1 monoclonal antibody to kallikrein which blocks the activation of bradykinin, a potent vasodilator responsible for the attacks of swelling, inflammation and pain in hereditary angioedema (HAE). Lanadelumab has been linked to a low rate of serum enzyme elevations during therapy, but has not been implicated in instances of clinically apparent acute liver injury.

### Background

Lanadelumab (lan" a del' ue mab) is a human IgG1 monoclonal antibody to kallikrein, which inhibits its proteolytic activity, blocking the formation of bradykinin, a potent vasodilator, levels of which are increased during attacks of hereditary angioedema. HAE is a rare genetic disorder due to C1-inhibitor deficiency, an important mediator and regulator of plasma kallikrein activity. In clinical trials in patients with recurrent attacks of HAE, lanadelumab was found to reduce the frequency and severity of attacks and improve functional activity and quality of life. Lanadelumab was approved for use in HAE in the United States in 2018 and is currently available as a solution in single dose vials of 300 mg in 2 mL (150 mg/mL) under the commercial name Takhzyro. The recommended dose is 300 mg subcutaneously every 2 or 4 weeks. Side effects are not common, but can include injection site reactions, upper respiratory infections, headache, dizziness, myalgia, rash and diarrhea. Rare, but potentially severe adverse reactions include hypersensitivity reactions.

### Hepatotoxicity

In preregistration trials in patients with HAE, serum ALT levels were elevated above 3 times the upper limit of normal in 6% of lanadelumab vs 0% of placebo recipients, but there were no instances of concurrent elevations in serum bilirubin and aminotransferase levels. The serum ALT and AST elevations generally arose after a month of therapy and continued to occur throughout treatment with no particular pattern. There were no hepatic serious adverse events, and only one patient discontinued lanadelumab early because of serum aminotransferase elevations (peak ALT 153 U/L), which resolved upon stopping. Since its approval, there have been no published cases of clinically apparent liver injury attributed to lanadelumab therapy, although the clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lanadelumab might cause liver injury is unknown. Lanadelumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity. Inhibition of plasma kallikrein activity would not be expected to cause liver injury.

### Outcome and Management

Lanadelumab therapy has been linked to rare instances of mild, transient serum enzyme elevations during therapy, typically arising at least a month after starting therapy. In patients who develop persistent elevations of serum ALT or alkaline phosphatase levels above 3 times ULN or who develop jaundice and symptoms, therapy should be interrupted.

Drug Class: Hematologic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lanadelumab – Takhzyro®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lanadelumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lanadelumab | 1426055-14-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Abbreviations used: HAE, hereditary angioedema.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of monoclonal agents used in immunosuppressive regimens; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; lanadelumab is not specifically mentioned).
Skidgel RA. Histamine, bradykinin, and their antagonists. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 711-26. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations above 3 times ULN occurred in 6% of lanadelumab vs 0% of placebo treated subjects with HAE, but all elevations were transient, anicteric and asymptomatic, although in some cases, they led to treatment discontinuation).
Kenniston JA, Faucette RR, Martik D, Comeau SR, Lindberg AP, Kopacz KJ, Conley GP, et al. Inhibition of plasma kallikrein by a highly specific active site blocking antibody. J Biol Chem 2014; 289: 23596-608. (Description of a human monoclonal antibody with potent and specific affinity for plasma kallikrein, the serine protease that cleaves HMWK to release bradykinin, the proinflammatory peptide that mediates pain, swelling, vasodilation and inflammation and appears to be responsible for the acute attacks that occur in patients with HAE, who are deficient in serpin C1 inhibitor that regulates the kallikrein-kinin enzymatic pathway). 24970892
Banerji A, Busse P, Shennak M, Lumry W, Davis-Lorton M, Wedner HJ, Jacobs J, et al. Inhibiting plasma kallikrein for hereditary angioedema prophylaxis. N Engl J Med 2017; 376: 717-28. (Among 37 patients with HAE treated with 2 injections of lanadelumab [at 1 of 4 doses] or placebo 2 weeks apart, acute attacks were less in those given in highest doses [300 or 400 mg], adverse event rates were lower and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 28225674
Banerji A, Riedl MA, Bernstein JA, Cicardi M, Longhurst HJ, Zuraw BL, Busse PJ, et al.; HELP Investigators. Effect of lanadelumab compared with placebo on prevention of hereditary angioedema attacks: a randomized clinical trial. JAMA 2018; 320: 2108-21. (Among 125 patients with HAE in a placebo-controlled trial for 26 weeks, the mean monthly number of attacks was less with lanadelumab [0.26 and 0.48] than placebo [1.97], while adverse events that were more frequent were injection site reactions and headaches; one patient had elevations of ALT [140 U/L] and AST [143 U/L] during treatment that resolved with discontinuation). 30480729
Syed YY. Lanadelumab: first global approval. Drugs 2018; 78: 1633-7. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, safety and ongoing evaluation of lanadelumab as a means of prevention of HAE; mentions that aminotransferase elevations occurred with treatment but were "generally asymptomatic and transient, and were not serious"). 30267321
Busse PJ, Farkas H, Banerji A, Lumry WR, Longhurst HJ, Sexton DJ, Riedl MA. Lanadelumab for the prophylactic treatment of hereditary angioedema with C1 inhibitor deficiency: a review of preclinical and phase I studies. BioDrugs 2019; 33: 33-43. (In phase 1 studies of lanadelumab there were "no clinically meaningful abnormalities or changes in laboratory parameters"). 30539362

## OTHER REFERENCE LINKS

1. Recent References on Lanadelumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lanadelumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lanadelumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lanadelumab)